# Moxetumomab Pasudotox

## OVERVIEW

### Introduction

Moxetumomab pasudotox is a mouse monoclonal antibody to CD22 conjugated with a toxic fragment of Pseudomonas exotoxin A which is used in the therapy of resistant forms of hairy cell leukemia. Moxetumomab pasudotox has been linked to transient serum enzyme elevations during therapy, but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Moxetumomab (mox" e toom' oh mab) pasudotox (pa soo' doe tox) is a recombinant mouse monoclonal antibody to the human CD22 cell surface marker which is highly expressed on the malignant B cells of hairy cell leukemia. The monoclonal antibody is conjugated to a fragment of a bacterial toxin, Pseudomonas exotoxin PE38 (pasudotox). When moxetumomab binds to CD22 on malignant B cells, it is internalized and the pasudotox is released by the action of lysosomal enzymes on the linker molecule that joins the monoclonal antibody and cytotoxic molecule. The intracellular exotoxin results in apoptotic cell death. This monoclonal antibody conjugate has been shown to be effective in inducing remissions in relapsed or refractory hairy cell leukemia and was given accelerated approval for this indication in the United States in 2018. Moxetumomab pasudotox is available in single dose vials of 1 mg of lyophilized powder under the brand name Lumoxiti. The recommended dose is 0.04 mg/kg by intravenous infusion over 30 minutes on days 1, 3 and 5 of each 28-day cycle. Premedication with acetaminophen, an antihistamine and H2 receptor blocker is recommended as well as careful attention to maintaining adequate hydration. Common side effects include infusion reactions, edema, nausea, fatigue, headache, fever, diarrhea, constipation and anemia. Less common but serious side effects include severe infusion reactions, hemolytic uremic syndrome, capillary leak syndrome, renal toxicity and electrolyte imbalance.

### Hepatotoxicity

In publications on trials of moxetumomab pasudotox in hairy cell leukemia, serum ALT or AST elevations were frequent during therapy arising in 14% to 19% of patients, but to above 5 times the upper limit of normal (ULN) in only 3.8% to 5.5%. Serial testing for ALT and AST during moxetumomab therapy shows regular and reproducible elevations occurring with each cycle of treatment, peaking at or around day 8 and falling back to baseline by day 21. Hyperbilirubinemia was also common during moxetumomab therapy (6.3%), but there were no reported instances of clinically apparent liver injury with symptoms and jaundice that were attributed to the monoclonal-toxin conjugate. The major severe adverse reactions to moxetumomab pasudotox therapy were hemolytic uremic syndrome and capillary leak syndrome, both of which may be associated with mild-to-moderate serum enzyme elevations, but significant liver injury with jaundice is rare. In addition, moxetumomab pasudotox has not been linked to sinusoidal obstruction syndrome, a common complication of other monoclonal-toxin conjugates.

Likelihood score: E* (unproven but suspected possible cause of clinically apparent liver injury).

### Mechanism of Injury

The serum enzyme elevations that occur during moxetumomab pasudotox therapy is not known, but it is likely direct toxicity of the conjugate.

### Outcome and Management

The serum enzyme elevations during moxetumomab pasudotox therapy are common but generally transient, mild and asymptomatic and rarely require dose modification or delay in therapy. Elevations of ALT or AST above 5 times the ULN should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal values.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Moxetumomab Pasudotox – Lumoxiti®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Moxetumomab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Moxetumomab Pasudotox | 1020748-57-5 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

DeLeve LD. Gemtuzumab ozogamicin. Liver sinusoidal endothelial cells and liver injury. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 142-3. (Review of agents that damage liver sinusoidal cells including gemtuzumab ozogamicin; mentions that CD33 which is present on leukemic blast cells is also present on liver sinusoidal endothelial cells; moxetumomab is not discussed, but there is no evidence linking CD22 or moxetumomab pasudotox to similar effects).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that serum ALT or AST elevations arose in 21-39% of patients treated with moxetumomab and were above 5 times ULN in 1.3-3.1%, but no patient developed acute liver injury with jaundice).
Dhillon S. Moxetumomab pasudotox: first global approval. Drugs 2018; 78 (16): 1763-7. (Review of the current status of therapy of hairy cell leukemia and the development, structure, mechanism of action, pharmacology, clinical efficacy and safety of moxetumomab pasudotox; mentions serious adverse events of fever, sepsis, hemolytic uremic syndrome, capillary leak syndrome and renal dysfunction; no mention of ALT elevations or hepatotoxicity). 30357593
Kreitman RJ, Dearden C, Zinzani PL, Delgado J, Karlin L, Robak T, Gladstone DE, et al. Moxetumomab pasudotox in relapsed/refractory hairy cell leukemia. Leukemia 2018; 32: 1768-77. (Among 80 adults with relapsed or refractory hairy cell leukemia treated with moxetumomab pasudotox, durable complete responses occurred in 30% and clinical remissions in 80%, while adverse events included peripheral edema [39%], nausea [35%], fatigue [34%], headache [33%], hemolytic uremic syndrome [7.5%] and capillary leak syndrome [5%]; ALT elevations arose in 21%, but only 1.3% were above 5 times ULN and no patient had clinically apparent liver injury with jaundice). 30030507

## OTHER REFERENCE LINKS

1. Recent References on Moxetumomab Pasudotox: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Moxetumomab%20Pasudotox+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Moxetumomab Pasudotox: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Moxetumomab%20Pasudotox)